# Bempedoic Acid

## OVERVIEW

### Introduction

Bempedoic acid is a small molecule inhibitor of adenosine triphosphate-citrate lyase that is used as a cholesterol lowering agent in patients with hypercholesterolemia and high risk or with known atherosclerotic cardiovascular disease who fail to have an adequate response or are intolerant of conventional statin therapy. Bempedoic acid is associated with a low rate of mild, asymptomatic and self-limited serum aminotransferase elevations during therapy and to rare instances of clinically apparent acute liver injury.

### Background

Bempedoic (bem” pe doe’ ik) acid is an orally available, small molecule inhibitor of adenosine triphosphate-citrate lyase (ACL), a hepatic enzyme involved in cholesterol synthesis. Inhibition of ACL results in a lowering of intrahepatic cholesterol levels which leads to an increase in LDL cholesterol (LDL-C) receptors on hepatocytes and increased uptake of LDL-C from serum resulting in lower serum levels. In large, randomized placebo-controlled trials, bempedoic acid resulted in a 17% to 24% decrease in LDL cholesterol levels. Bempedoic acid was approved for use in the United States in 2020 as an adjunct to diet and statins for control of LDL cholesterol levels in patients with heterozygous familial hypercholesterolemia or patients with established atherosclerotic cardiovascular disease who fail to have an adequate response or are intolerant of conventional statin therapy. Bempedoic acid has been shown to decrease the risk of morbidity and mortality from atherosclerotic cardiovascular disease but with less efficacy than statins, for which reason it is generally reserved for patients who have an inadequate response to maximal tolerated doses of statins. Bempedoic acid is available under the brand name Nexletol in tablets of 180 mg and the recommended dose is 180 mg once daily. Common side effects include symptoms of upper respiratory infection, muscle cramps and pain, back pain, abdominal pain, hyperuricemia, bronchitis, headache, nausea, and weakness. Rare but potentially severe adverse events include severe hyperuricemia and tendon rupture.

### Hepatotoxicity

Bempedoic acid is associated with low rate of mild, asymptomatic and typically transient serum aminotransferase elevations during therapy. In prelicensure controlled trials, elevations in either ALT or AST arose in 2% of treated patients compared to less than 1% of placebo recipients. ALT elevations above 3 times the upper limit of normal (ULN) arise in less than 1% of bempedoic treated patients, a rate similar to that in placebo recipients (most of the participants were taking other cholesterol lowering agents such as statins or ezetimibe). There were no instances of serum ALT elevations associated with symptoms or jaundice in the prelicensure trials. Since the approval and more widespread use of bempedoic acid, there have been no published reports of clinically apparent liver injury attributed to its use.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The potential cause of hepatic injury from bempedoic acid is unknown. It is metabolized in the liver (via CYP 2C9). The mild, self-limited ALT elevations may be due to a toxic intermediate of drug metabolism and the reversal of these elevations due to adaptation.

### Outcome and Management

The serum enzyme elevations that sometimes arise in patients taking bempedoic acid generally resolve even without dose modification or discontinuation. There is no evidence for cross sensitivity to hepatic injury among the various cholesterol lowering drugs.

Drug Class: Antilipemic Agents

Other Drugs in the Subclass, Statins: Atorvastatin, Ezetimibe [used in combination]

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Bempedoic Acid – Nexletol®

DRUG CLASS

Antilipemic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Bempedoic%20Acid)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Bempedoic Acid | 738606-46-7 | C19-H36-O5

## ANNOTATED BIBLIOGRAPHY

References updated: 15 July 2023

Abbreviations used: HDL, high density lipoprotein; LDL, low density lipoprotein; ULN, upper limit of the normal range.

Zimmerman HJ. Drugs used in the treatment of hypercholesterolemia and hyperlipidemia. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 660-2. (Expert review of hepatotoxicity published in 1999 before the availability of bempedoic acid).
Gurgle H, Blumenthal DK. Drug therapy for dyslipidemias. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 605-618. (Textbook of pharmacology and therapeutics).
FDA: https://www.accessdata.fda.gov/drugsatfda_docs/nda/2020/211616Orig1s000IntegratedR.pdf (FDA website with product labels and FDA review of the safety and efficacy of bempedoic acid based upon submission of data by the sponsor in support of its approval, mentions that in a large preregistration trial, ALT elevations above 3 times the upper limit of normal arose in less than 1% of treated patients and at a rate similar to that of patients receiving placebo).
Pinkosky SL, Newton RS, Day EA, Ford RJ, Lhotak S, Austin RC, Birch CM, et al. Liver-specific ATP-citrate lyase inhibition by bempedoic acid decreases LDL-C and attenuates atherosclerosis. Nat Commun. 2016;7:13457. (Demonstration that bempedoic acid inhibits ATP-citrate lyase [ACL], a cytoplastic enzyme involved in synthesis of cholesterol upstream of HMG-CoA reductase, the target of statins; ACL is found in liver but not muscle cells and thus might lower cholesterol levels without causing myalgias and myopathy). 27892461
Ray KK, Bays HE, Catapano AL, Lalwani ND, Bloedon LT, Sterling LR, Robinson PL, et al.; CLEAR Harmony Trial. Safety and efficacy of bempedoic acid to reduce LDL cholesterol. N Engl J Med. 2019;380:1022-1032. (Among 2230 patients with heterozygous familial hypercholesterolemia or with known atherosclerotic cardiovascular disease and LDL cholesterol levels above 70 mg/dL on maximal tolerated doses of statins who were treated with bempedoic acid [180 mg] or placebo once daily for 52 weeks, LDL cholesterol levels decreased by an average of 19.2 mg/dL or -16.5% on bempedoic acid compared to an increase of 1% in placebo recipients, while total and serious adverse event rates were similar in the two groups, and ALT or AST elevations above 3 times ULN arose in 0.5% vs 0.1%, and there were no liver related deaths or serious adverse events). 30865796
Bays HE, Banach M, Catapano AL, Duell PB, Gotto AM Jr, Laufs U, Leiter LA, et al. Bempedoic acid safety analysis: Pooled data from four phase 3 clinical trials. J Clin Lipidol. 2020;14:649-659.e6. (Analysis of adverse event rates in pooled results from 4 randomized, placebo-controlled trials of bempedoic acid in patients with hypercholesterolemia found overall adverse event rates per 100 patient exposure years similar in the two groups [87.1 vs 82.9] but discontinuations of adverse events more frequent with bempedoic acid [13.4 vs 8.9], while ALT elevations above 3 times ULN were uncommon [0.8 vs 0.3] all of which were transient and not associated with jaundice). 32980290
Bempedoic acid (Nexletol) for lowering LDL-cholesterol. Med Lett Drugs Ther. 2020;62:53-55. (Concise review of the mechanism of action, clinical efficacy, safety and costs of bempedoic acid, mentions that therapy has been linked to elevations in liver enzymes but does not mention clinically apparent hepatotoxicity and does not recommend monitoring ALT or AST). 32324179
Lipid-lowering drugs. Med Lett Drugs Ther. 2022;64:145-152. (Concise review of the mechanism of action, relative efficacy, safety and costs of lipid lowering drugs including statins, ezetimibe, PCSK9 inhibitors, bile acid sequestrants, fibric acid derivatives, niacin, fish oil, and bempedoic acid, mentions that it can cause elevations in liver enzymes). 36094548
Ballantyne CM, Banach M, Bays HE, Catapano AL, Laufs U, Stroes ESG, Robinson P, et al. Long-term safety and efficacy of bempedoic acid in patients with atherosclerotic cardiovascular disease and/or heterozygous familial hypercholesterolemia (from the CLEAR Harmony Open-Label Extension Study). Am J Cardiol. 2022;174:1-11. (Among 1462 patients with hypercholesterolemia who participated in the 52 week, randomized placebo- controlled trial of bempedoic acid [Ray, 2019] and were then enrolled in a 78 week open-label extension study, the cholesterol lowering effect of therapy was maintained and no new safety issues arose, laboratory abnormalities did not worsen, and ALT elevations arose in only 5 subjects [0.3%]). 35483979
In brief: Cardiovascular outcomes with bempedoic acid (Nexletol). Med Lett Drugs Ther. 2023;65: 62-63. (Concise summary of recent trial of bempedoic acid vs placebo in 13,970 patients with intolerance to statins and high risk for cardiovascular disease followed for a median of 42 months, found a reduction in a combined endpoint of myocardial infarction, stroke, cardiovascular death and coronary revascularization with bempedoic acid [11.7% vs 13.3%] and lowering of LDL cholesterol by 21% vs 0.8%; no mention of ALT elevations or hepatotoxicity). 37039614
Banach M, Penson PE, Farnier M, Fras Z, Latkovskis G, Laufs U, Paneni F, et al. Bempedoic acid in the management of lipid disorders and cardiovascular risk. 2023 position paper of the International Lipid Expert Panel (ILEP). Prog Cardiovasc Dis. 2023:S0033-0620(23)00026-9. (Expert opinion recommendations on the use of bempedoic acid in management of dyslipidemia mentions that it is associated with a small increase in the rate of aminotransferase elevations to above 3 times ULN [0.8 vs 0.3 per 100 patient-years of exposure to drug vs placebo], but that the effect is transient and reversible upon discontinuation).
Nissen SE, Lincoff AM, Brennan D, Ray KK, Mason D, Kastelein JJP, Thompson PD, et al.; CLEAR Outcomes Investigators. Bempedoic acid and cardiovascular outcomes in statin-intolerant patients. N Engl J Med. 2023;388:1353-1364. (Among 13,970 adults with hypercholesterolemia and statin-intolerance treated with bempedoic acid [180 mg] or placebo once daily for a median of 41 months, the combined primary endpoint of non-fatal myocardial infarction, non-fatal stroke, cardiovascular death, and coronary revascularization was less frequent in bempedoic acid treated patients [13.3% vs 11.7%] as was myocardial infarction [3.7% vs 4.8%] and LDL-cholesterol levels lower [-21% vs -1%], but adverse event rates were similar between the two groups except for slight increases in rates of ALT elevations above 3 times ULN [1.2% vs 0.8%], gout [3.1% vs 2.1%] and cholelithiasis [2.2% vs 1.2%], but there were no serious hepatic adverse events). 36876740

## OTHER REFERENCE LINKS

1 Recent References on Bempedoic Acid: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Bempedoic+Acid+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Bempedoic Acid: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Bempedoic%20Acid)